# Sulfadoxine-Pyrimethamine

## OVERVIEW

### Introduction

The combination of sulfadoxine and pyrimethamine is used in the treatment and prophylaxis of chloroquine resistant strains of malaria and the treatment of toxoplasmosis. Sulfadoxine-pyrimethamine has been linked with rare cases of idiosyncratic liver injury which resembles the hepatotoxicity associated with sulfonamides.

### Background

Pyrimethamine (pir" i meth' a meen) is a diamino-pyrimidine and anti-folate, similar in structure and activity to proguanil, which has potent inhibitory activity against malaria parasites as well as Toxoplasma gondii. Pyrimethamine has profound antimalarial synergy with sulfonamides and has been widely used in combination with sulfadoxine (sul" fa dox' een) as prophylaxis and treatment of chloroquine-resistant malaria. In recent years, this combination has been replaced by other approaches, partially because of the frequency of hypersensitivity reactions including hepatotoxicity. Pyrimethamine-sulfadoxine is no longer available in the United States, other antimalarials combination being considered more effective and better tolerated. However, it is still used for treatment of malaria (particularly in Africa) and for prophylaxis against chloroquine-resistant malaria in patients with contraindications to other agents. This combination was available under the brand name of Fansidar in tablets that combined 25 mg of pyrimethamine with 500 mg of sulfadoxine. Pyrimethamine was also available separately as 25 mg tablets in generic forms and under the commercial name Daraprim for use in therapy of toxoplasmosis in combination with a sulfonamide. Pyrimethamine should not be used alone, either for treatment of toxoplasmosis or malaria. Sulfadoxine-pyrimethamine is reasonably well tolerated but like other sulfonamides has possible side effects including fatigue, weakness, insomnia, dizziness, headache, nausea, diarrhea, and rash. Rare but potential severe adverse events include hypersensitivity reactions, drug rashes, Drug Reaction with Eosinophilia and Systemic Symptoms (DRESS), Stevens-Johnson syndrome, toxic epidermal necrolysis, aplastic anemia, agranulocytosis, thrombocytopenia, anaphylaxis, and embryo-fetal toxicity.

### Hepatotoxicity

Sulfadoxine-pyrimethamine can cause clinically apparent, idiosyncratic liver injury with prominent features of drug-allergy or hypersensitivity, as is typical of sulfonamide hepatotoxicity. The typical onset is sudden development of fever and rash followed by jaundice within a few days or weeks of starting the medication. The pattern of injury is typically cholestatic or mixed and can be complicated and prolonged. This combination has also been linked to cases of acute liver failure with marked hepatocellular injury. However, most cases resolve rapidly, usually within 2 to 4 weeks unless cholestasis is severe. Mild ALT elevations without jaundice can accompany hypersensitivity reactions to the sulfonamides and may be accompanied by hepatic granulomas. Reexposure leads to a more rapid onset of injury and should be avoided (as should use of other sulfonamides). It is not clear whether pyrimethamine is capable of causing liver injury on its own, largely because it is used only in combination with a sulfonamide.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The clinical pattern of injury with sulfadoxine suggests a drug-allergy or hypersensitivity mechanism, perhaps through its metabolism to a toxic, reactive or antigenic metabolite.

### Outcome and Management

Sulfadoxine-pyrimethamine induced liver injury can result in acute liver failure, but most cases resolve rapidly with discontinuation of drug, and full recovery is expected within 2 to 8 weeks. Cases in which granulomatous hepatitis was identified on liver biopsy have been described, but the clinical course is not distinctive. Liver injury is usually a part of a systemic hypersensitivity reaction, and some cases can be categorized as DRESS syndrome (drug rash with eosinophilia and systemic symptoms). Rechallenge should not be done, and patients should be told that they are allergic to sulfonamides (“sulfa-drugs”) and not receive other drugs in this class. Prednisone has been used with variable success, but may be particularly helpful in patients with prominent allergic features with systemic features and fever, severe rash, arthralgias, lymphadenopathy and eosinophilia or atypical lymphocytosis.

Drug Class: Antiinfective Agents, Sulfonamides; Antimalarial Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sulfadoxine-Pyrimethamine – Fansidar®

DRUG CLASS

Antiinfective Agents; Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pyrimethamine+sulfadoxine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Pyrimethamine- Sulfadoxine | 37338-39-9 | C12-H14-N4-O4-S. C12-H13-Cl-N4 | SID:135260144

## ANNOTATED BIBLIOGRAPHY

References updated: 10 January 2026

Abbreviations: TMP-SMZ, trimethoprim and sulfamethoxazole; DRESS, drug reaction with eosinophilia and systemic symptoms; iv, intravenous; HLA, human leukocyte antigen.

Zimmerman HJ. Sulfonamides. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 606-9. (Expert review of the sulfonamides and sulfones published in 1999; sulfonamides are thought to cause clinically apparent liver injury in 0.5-1.0% of recipients generally with a sudden onset within 14 days of starting, often with immunoallergic features and a hepatocellular or mixed pattern of injury; mortality may be as high as 10%).
Moseley RH. Sulfonamides. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics including sulfonamides).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-1021. (Textbook of pharmacology and therapeutics).
Vinetz JM. Chemotherapy of malaria. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 967-986. (Textbook of pharmacology and therapeutics, mentions that the combination of sulfadoxine and pyrimethamine was a primary treatment for uncomplicated P. falciparum malaria, but is no longer recommended because of a high rate of resistance and its potential for liver and hypersensitivity related adverse events).
Lowe J, Smith M. The chemotherapy of leprosy in Nigeria; with an appendix on glandular fever and exfoliative dermatitis precipitated by sulfones. Int J Lepr 1949; 17: 181-95. (Summary of clinical results in using sulfones in 227 patients with leprosy described "Glandular fever and exfoliative dermatitis precipitated by sulfones" in the appendix: occurring mostly in adult men, the dermatitis in 2%, glandular fever in 12% which was marked by fever, lymphadenitis, splenomegaly and jaundice in some cases: initial description of sulfone-syndrome). 15399690
Fries J, Siragenian R. Sulfonamide hepatitis. Report of a case due to sulfamethoxazole and sulfisoxazole. N Engl J Med 1966; 274: 95-7. (60 year old woman developed jaundice after 4 days of sulfamethoxazole with fever, arthralgias and rash [bilirubin 8.4 mg/dL, ALT 360 U/L, Alk P 2.5 times ULN], with positive rechallenge within 30 hours of starting sulfisoxazole [AST 396 U/L, Alk P 1.5 times ULN]). 5901208
Dujovne CA, Chan CH, Zimmerman HJ. Sulfonamide hepatic injury. Review of the literature and report of a case due to sulfamethoxazole. N Engl J Med 1967; 277: 785-8. (Classic description of sulfonamide hepatotoxicity: case report of a 38 year old man who developed jaundice after 14 days of sulfamethoxazole [3rd exposure] with positive rechallenge; review of the literature on over 100 cases: usual latency of 1-4 weeks, shorter on rechallenge, rash and fever common). 6046676
Espiritu CR, Kim TS, Levine RA. Granulomatous hepatitis associated with sulfadimethoxine hypersensitivity. JAMA 1967; 202: 985-8. (24 year old man developed rash and jaundice within a week of starting sulfadimethoxine [bilirubin 4.2 mg/dL, AST 72 U/L, Alk P ~ twice ULN], liver biopsy showing granulomatous hepatitis; and rapid recovery). 5630747
Iwarson S, Lundin P. Multiple attacks of jaundice associated with repeated sulfonamide treatment. Acta Med Scand 1979; 206: 219-22. (Four women, ages 20, 30, 35 and 68 years, who had repeated episodes of liver injury after sulfonamides with shortening of latency upon re-exposure, but no worsening of injury [usually hepatocellular] or slowing of resolution, which ranged from 4-12 weeks). 495230
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (572 reports of drug induced liver injury from 1968-78 were analyzed, representing 6% of total adverse reaction reports and 12% of those that were fatal; halothane accounted for 25% of cases, chlorpromazine 9%, sulfonamides 9%, antituberculosis agents 7%, oxyphenisatin 4% and methyldopa 2%). 6982502
Olsen VV, Loft S, Christensen KD. Serious reactions during malaria prophylaxis with pyrimethamine-sulfadoxine. Lancet 1982; 2: 994. (Briefly described case of 60 year old woman traveler who developed severe jaundice after 5 weeks of pyrimethamine-sulfadoxine [Fansidar] with fever and eosinophilia, ultimately recovered). 6127497
Koch-Weser J, Hodel C, Leimer R, Styk S. Adverse reactions to pyrimethamine/sulfadoxine. Lancet 1982; 2: 1459. (Industry response to letter by Olsen [1982] stressing the safety of Fansidar; among 1.5 million exposed persons, only 24 cases of liver reactions have been reported to sponsor). 6129527
Lazar HP, Murphy RL, Phair JP. Fansidar and hepatic granulomas. Ann Intern Med 1985; 102: 722. (Two women, aged 69 and 75 years, taking sulfadoxine and pyrimethamine for prophylaxis against malaria developed fever, rash and enzyme elevations with liver biopsies showing granulomas). 3985527
Selby CD, Ladusans EJ, Smith PG. Fatal multisystemic toxicity associated with prophylaxis with pyrimethamine and sulfadoxine (Fansidar). Br Med J (Clin Res Ed) 1985; 290: 113-4. (60 year old traveler developed fever and rash 3 weeks after starting Fansidar [bilirubin rising to 22.5 mg/dL, Alk P 809 U/L, ALT 89 U/L], dying two weeks later with severe rash and renal failure). 3155635
Curley RK, Macfarlane AW. Fatal multisystemic toxicity associated with prophylaxis with pyrimethamine and sulfadoxine. Br Med J (Clin Res Ed) 1985; 290: 471-2. (Toxic epidermal necrolysis [TEN] arose after 9 days of sulfasalazine and subsequent jaundice with little information on enzymes; death appeared to be complication of TEN and corticosteroid use with herpes, septicemia, and shock). 2857586
Murphy RL, Phair JP. Systemic reaction to pyrimethamine-sulfadoxine. J Fam Pract 1986; 22: 375-6. (75 year old woman developed fever, rash, eosinophilia, and cholestatic liver enzymes [AST 53 U/L, Alk P 364 U/L] without jaundice after 4 weeks of sulfadoxine-pyrimethamine therapy; liver biopsy showed granulomas). 3958686
Wejstal R, Lindberg J, Malmvall BE, Norkrans G. Liver damage associated with Fansidar. Lancet 1986; 1: 854-5. (Seven cases of jaundice attributed to sulfadoxine-pyrimethamine [Fansidar] prophylaxis against malaria; cases arose after 2-12 weeks of therapy, were usually hepatocellular and 6 were jaundiced [bilirubin 0.7-15.2 mg/dL, Alk P 1-2 times normal, ALT 20-90 times normal], resolving within 4-12 weeks of stopping). 2870335
Zitelli BJ, Alexander J, Taylor S, Miller KD, Howrie DL, Perez TH, Van Thiel DH. Fatal hepatic necrosis due to sulfadoxine-pyrimethamine (Fansidar). Ann Intern Med 1987; 106: 393-5. (15 year old girl developed fever, rash and jaundice after third weekly dose of sulfadoxine-pyrimethamine [bilirubin rising from 0.6 to 8.5 mg/dL, ALT 763 U/L, Alk P 669 U/L, atypical lymphocytosis]; patient ultimately died of acute liver failure). 2949680
Phillips-Howard PA, West LJ. Serious adverse drug reactions to pyrimethamine-sulphadoxine, pyrimethamine-dapsone and to amodiaquine in Britain. J R Soc Med 1990; 83: 82-5. (Spontaneous reporting of serious liver injury in 1:75,000 prescriptions for pyrimethamine-dapsone [Maloprim] for malaria prophylaxis in the UK). 2138674
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; 62 cases [5%] were attributed to either TMP-SMZ or SMZ alone but none to sulfadoxine-pyrimethamine). 1506809
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; TMP-SMZ accounted for 29 (ranking 9th), 1 case being fatal). 8816722
Slatore CG, Tilles SA. Sulfonamide hypersensitivity. Immunol Allergy Clin North Am 2004; 24: 477-90, vii. PMID: 15242722 (Review of mechanisms of hypersensitivity to sulfonamides).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to sulfasalazine and 1 to TMP-SMZ but none to sulfadoxine-pyrimethamine). 15390328
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network between 1994-2004, included 461 cases of drug induced liver disease; sulfonamides were not mentioned in the top 19 causes [drugs with 5 or more cases]). 16083708
Garcia Rodriguez LA, Ruigomez A, Jick H. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine but none to sulfadoxine-pyrimethamine [~10% overall]). 16165719
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: PMID: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; dapsone accounted for 17 cases [5.4%] of which 2 were fatal, and TMP-SMZ accounted for 7 cases [2.2%], but none attributed to sulfadoxine-pyrimethamine).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 12 due to sulfonamides [9%], 9 due to TMP-SMZ, and 3 due to sulfasalazine but none to sulfadoxine-pyrimethamine). 20949552
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to sulfonamides). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases were attributed to TMP-SMZ, 2 cases to dapsone, but none to sulfadoxine-pyrimethamine). 25754159
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol 2017; 112: 1382-8. (Among 985 patients enrolled in a US prospective database of drug induced liver injury between 2004 and 2016, SMZ/TMP was the most implicated medication among 144 African Americans [7.6%], but ranked fifth among 841 Caucasians [3.6%] behind amoxicillin-clavulanate, nitrofurantoin, anabolic steroids and isoniazid). 28762375
Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575.. (Among 105 cases of sulfonamide induced liver injury enrolled in a prospective U.S. database between 2004 and 2020, 93 were attributed to TMP-SMZ, 9 to sulfasalazine, 2 to dapsone, 1 to sulfadiazine, but none to sulfadoxine-pyrimethamine). 36848311
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, only 3 were attributed to TMP-SMZ, 3 to sulfadiazine, 2 to dapsone, and one to sulfasalazine). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Sulfadoxine-Pyrimethamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=sulfadoxine/AE+AND+pyrimethamine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sulfadoxine-Pyrimethamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sulfadoxine+pyrimethamine)